# Organic Nitrates

## OVERVIEW

### Introduction

The organic nitrates, including nitroglycerin, isosorbide dinitrate and isosorbide mononitrate, act as prodrugs for nitric oxide and are used to treat or prevent acute attacks of angina pectoris. These agents have been in wide scale use for many decades and have not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

The organic nitrates, including nitroglycerin, isosorbide dinitrate and isosorbide mononitrate, act as prodrugs for nitric oxide (NO) which is a potent vasodilator gas. Nitric oxide activates guanylyl-cyclase in vascular endothelial cells, which increases intracellular cyclic GMP and thereby reduces intracellular calcium concentrates and dephosphorylates myosin light chains causing relaxation of smooth muscle cells. The effect of nitrates is largely on vascular endothelium, both arteries and veins, but predominantly veins, causing venous pooling and a decrease venous return to the heart, thus decreasing cardiac preload. Arteriolar relaxation reduces systemic vascular resistance and systolic blood pressure decreasing cardiac afterload. Nitrates also cause increase in coronary blood flow. These combined effects decrease myocardial oxygen demand and relieves ischemia. Nitrates are typically given sublingually and have a rapid onset of action and somewhat short duration of action. Long acting formulations and transdermal, oral, intravenous, aerosol spray and other formulations are available that can be used chronically and for prevention of angina attacks. Nitroglycerin is typically used to treat an acute attack of angina (or in anticipation of an acute attack as with exercise or stress). Isosorbide dinitrate and mononitrate are typically given chronically to prevent angina attacks. However, nitrate tolerance develops rapidly with persistent exposure and these agents are given in a way that allows for an 8 to 12 hour nitrate free period to restore efficacy. The three forms of organic nitrates are described separately in this document, but their mechanism of action is similar as are their clinical effects and adverse event profiles.

Nitroglycerin (nye" troe glis' er in) is a propanetriol trinitrate, a nitric oxide prodrug that has been in common use as a treatment for acute angina pectoris for more than 100 years. Current indications include treatment and prevention of angina attacks and management of acute coronary syndromes. Nitroglycerin is highly volatile and is formulated in a matrix that stabilizes the molecule. However, it is still susceptible to inactivation and is generally provided in a light-proof bottle with a short shelf life (6 months). Nitroglycerin is well absorbed orally but has a high first pass clearance by the liver, for which reason it is typically given sublingually or by transdermal routes. However, nitroglycerin is available generically in many forms, sublingual tablets, topical ointments, transdermal patches, transmucosal ointments, aerosolized sprays, extended release oral tablets and liquid solutions for intravenous use. The typical sublingual dose is 0.3 to 0.6 mg at the onset of angina pain or in anticipation of angina. The dose can be repeated every 5 minutes for 15 to 30 minutes for a maximum of 3 doses. The onset of action is within 2 to 5 minutes. The oral and transdermal forms are used largely for prevention of angina and long term therapy. Side effects of nitroglycerin include headache, dizziness, weakness, flushing, syncope, tachycardia, palpitations and postural hypotension. Dermal forms can cause local rash and irritation.

Isosorbide dinitrate (eye" soe sor' bide dye nye' trate) is a prodrug of nitric oxide used to treat as well as prevent attacks of angina pectoris. Isosorbide dinitrate is well absorbed orally, but undergoes extensive first pass metabolism by the liver for which reason it is typically given sublingually. Isosorbide dinitrate was approved for use in the United States in 1966 and is still in wide scale use. It is available in sublingual as well as oral extended release tablets and capsules generically and under several brand names such as Isordil, Dilatrate-SR and Sorbitrate. The sublingual forms for treatment of acute angina attacks are generally given in doses of 2.5 to 5 mg, repeated at 5 to 10 minute intervals for a maximum of 3 doses. The oral extended release forms are given in doses of 4 to 40 mg two to four times daily. A daily, 8 to 10 hour nitrate free period is recommended as diminished efficacy can occur due to nitrate tolerance with continuous use. Side effects of isosorbide dinitrate include headache, dizziness, weakness, flushing, syncope, tachycardia, palpitations and postural hypotension.

Isosorbide mononitrate (eye" soe sor' bide mon" oh nye' trate) is a prodrug of nitric oxide used to prevent (but not to treat) attacks of angina pectoris. Isosorbide mononitrate is well absorbed orally but, unlike nitroglycerin, does not undergo first pass metabolism by the liver and can be given in typical oral forms. Isosorbide mononitrate was approved for use in the United States in 1991 for prophylaxis of angina. It is available in generically and under the brand name ISMO and Monoket in tablets of 10 and 20 mg. The recommended dose regimen is 20 mg twice daily given 7 hours apart (thus with a 10 hour rest period to avoid nitrate tolerance). Isosorbide mononitrate is also available in extended release forms generically and under the brand name Imdur in 30, 60 and 120 mg tablets, the recommended initial dose being 30 to 60 mg once daily, gradually increasing to a maximum of 240 once daily. Side effects of isosorbide dinitrate include headache, dizziness, weakness, nausea and vomiting, peripheral edema, flushing, syncope, tachycardia, palpitations and postural hypotension.

### Hepatotoxicity

Despite many decades of wide scale use, nitroglycerin, isosorbide dinitrate and isosorbide mononitrate have not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

Likelihood score: E (unlikely causes of clinically apparent acute liver injury).

### Mechanism of Injury

The organic nitrates are rapidly metabolized to release nitric oxide in many tissues and are unlikely to have a direct toxic effect on the liver and also unlikely to cause idiosyncratic metabolic or immunoallergic injury.

### Outcome and Management

No convincing instances of clinically apparent or severe acute liver injury have been linked to organic nitrates in the published literature.

Drug Class: Antiangina Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nitroglycerin – Generic

Isosorbide Dinitrate – Generic, Isordil®

Isosorbide Mononitrate – Generic, Imdur®, ISMO®, Monoket®

DRUG CLASS

Antiangina Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Organic+Nitrates)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Nitroglycerin | 55-63-0 | C3-H5-N3-O9 | Nitroglycerin Chemical Structure
Isosorbide Dinitrate | 87-33-2 | C6-H8-N2-O8 | Isosorbide Dinitrate Chemical Structure
Isosorbide Mononitrate | 16051-77-7 | C6-H9-N-O6 | Isosorbide Mononitrate Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 27 April 2018

Zimmerman HJ. Organic Nitrates. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 653-4. (Textbook of hepatotoxicity published in 1999; mentions that "there has been no hint, during all the years of use of nitrate for angina, of resultant hepatic injury").
Michel T, Hoffman BB. Organic nitrates. Treatment of myocardial ischemia and hypertension. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 747-55. (Textbook of pharmacology and therapeutics).
Raubach KH, Vlahov V, Wolter K, Bussmann WD. Double-blind randomized multicenter study on the efficacy of trapidil versus isosorbide dinitrate in stable angina pectoris. Clin Cardiol 1997; 20: 483-8. (Among 95 patients with angina pectoris treated with isosorbide dinitrate or trapidil [a phosphodiesterase inhibitor], "tolerability was good" and there were no "clinically relevant alterations" in standard laboratory tests in either group). 9134282
Villanueva C, Balanzó J, Novella MT, Soriano G, Sáinz S, Torras X, Cussó X, et al. Nadolol plus isosorbide mononitrate compared with sclerotherapy for the prevention of variceal rebleeding. N Engl J Med 1996 Jun 20; 334 (25): 1624-9. (Among 86 patients with cirrhosis and variceal hemorrhage treated with sclerotherapy or nadolol and isosorbide dinitrate, recurrent bleeding was lower in the medically treated subjects and adverse events were less; no mention of worsening of liver tests or acute liver injury). 8628357
Chrysant SG, Glasser SP, Bittar N, Shahidi FE, Danisa K, Ibrahim R, Watts LE, et al. Efficacy and safety of extended-release isosorbide mononitrate for stable effort angina pectoris. Am J Cardiol 1993; 72: 1249-56. (Among 313 patients with angina pectoris treated with isosorbide mononitrate [30, 60, 120 or 240 mg daily] or placebo for 42 days, exercise tolerance was improved 4 and 12 hours after dosing, but not at 24 hours; common side effects were headache [38-75% vs 17%], dizziness, fatigue, and nausea: "Analyses of laboratory data did not reveal any finding consistent with drug-related toxicity"). 8256699
Hall R, Chong C. A double-blind, parallel-group study of amlodipine versus long-acting nitrate in the management of elderly patients with stable angina. Cardiology 2001; 96 (2): 72-7. (Among 97 elderly patients with angina treated with amlodipine or isosorbide mononitrate [25-50 mg once daily] for 28 weeks, exercise times improved more with amlodipine than nitrates, but adverse event rates were similar and there "were no clinically relevant changes in... clinical chemistry parameters"). 11740135
Wakai A, McCabe A, Kidney R, Brooks SC, Seupaul RA, Diercks DB, Salter N, et al. Nitrates for acute heart failure syndromes. Cochrane Database Syst Rev 2013; (8): CD005151. (Systematic review of controlled trials of nitrates for acute heart failure syndromes concluded that "nitrates appeared to be well tolerated", headaches being the most common side effect; no mention of ALT elevations or hepatotoxicity). 23922186
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to organic nitrates or agents for therapy of angina pectoris).

## OTHER REFERENCE LINKS

1. Recent References on Organic Nitrates: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Organic%20Nitrates+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Organic Nitrates: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Organic%20Nitrates)